# Infigratinib

## OVERVIEW

### Introduction

Infigratinib is a FGF receptor kinase inhibitor that is used in the treatment of unresectable, locally advanced or metastatic intrahepatic cholangiocarcinoma. Infigratinib is associated with transient and usually mild elevations in serum aminotransferase during therapy, but has not been convincingly linked to cases of clinically apparent liver injury.

### Background

Infigratinib (fue” ti ba’ ti nib) is an orally available, specific inhibitor of the fibroblast growth factor (FGF) receptor 1, 2 and 3 kinases, that is used in the therapy advanced or metastatic cholangiocarcinoma. Aberrant FGF receptor signaling is associated with several cancer types in which amplifications, translocations, fusings, and other activating point mutations of FGF receptors are found. Cholangiocarcinomas often harbor mutants of the FGF receptor 2 that cause the activation of FGF pathways that promote uncontrolled growth and tumorigenesis. Inhibition of the mutant receptor causes regression of cell proliferation and promotes cell death. Studies in cell culture and in animal models suggested that infigratinib was active in inhibiting cancer cell growth. Trials in patients with cholangiocarcinoma demonstrated a significant overall durable response rate, for which reason infigratinib received accelerated approval for use in the United States in 2021. Current indications are limited to adults with previously treated, unresectable, locally advanced, or metastatic intrahepatic cholangiocarcinoma with FGF receptor 2 gene fusions or other rearrangements. Infigratinib continues to be under evaluation for its long term safety and efficacy in cholangiocarcinoma and for its possible efficacy in other forms of cancer associated with FGF receptor gene alternations. Infigratinib is available in capsules of 25 and 100 mg under the brand name Truseltiq. The recommended dose is 125 mg once daily for 21 days of a 28 day cycle, continued indefinitely or until there is disease progression or unacceptable toxicity. Adverse events are common and include hyperphosphatemia (an effect of inhibition of FGF signaling), as well as symptoms of fatigue, nausea, diarrhea, constipation, dysgeusia, anorexia, abdominal pain, musculoskeletal pain, dizziness, alopecia, dryness of the eyes, mouth and skin, blurred vision, nail toxicity, and hand-foot syndrome. Severe adverse events include severe hyperphosphatemia, ocular toxicity, infections and sepsis, and embryo-fetal toxicity.

### Hepatotoxicity

In the open label clinical trials of infigratinib for advanced or metastatic cholangiocarcinoma, adverse events were common and led to dose interruptions in 64%, dose reductions in 60% of patients, and permanent discontinuations in 15% largely for hyperphosphatemia, infections and sepsis rather than liver injury. In preregistration trials in 108 patients, ALT elevations arose in 51% and to above 5 times ULN in 6%. The elevations were typically self-limited and resolved rapidly with or without dose adjustments. No patients developed clinically apparent liver injury or jaundice. Since its approval, there have been no reports clinically apparent liver injury attributed to infigratinib. However, the total clinical experience with its use has been limited and the frequency of serum aminotransferase elevations during therapy suggest that clinically significant liver injury may occur.

Likelihood score: E* (unproven but possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from infigratinib therapy are not known. Some of the adverse effects of infigratinib are due to its effects on FGF signaling (hyperphosphatemia) and others may be due to off-target effects on other kinases. Infigratinib is metabolized in the liver largely by CYP 3A4 and liver injury might be caused by production of a toxic or immunogenic intermediate. Because it is a substrate for CYP 3A4, infigratinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

Infigratinib is associated with a moderate rate of serum aminotransferase elevations that are generally transient and not associated with symptoms or jaundice. While regular monitoring of liver tests is not specifically recommended during infigratinib therapy, elevations if confirmed should lead to more careful follow up monitoring. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation until the abnormalities resolve or an alternative cause is identified. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity or hepatic injury between infigratinib and other protein kinases or FGF receptor inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other FGF Receptor Kinase Inhibitors: Erdafitinib, Futibatinib, Pemigatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Infigratinib – Truseltiq®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Infigratinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Infigratinib | 872511-34-7 | C26-H31-Cl2-N7-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2022

Abbreviations: FGF, fibroblast growth factor.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as infigratinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not the FGF receptor inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214622Orig1s000MultidisciplineR.pdf (FDA website with product labels, letters and multidisciplinary review of the applications for infigratinib mentions that adverse events were common, led to drug discontinuation in 15% [none liver related], interruptions in 64% and dose reductions in 60%; ALT elevations arose in 51% of 108 treated subjects which were above 5 times ULN in 6%, but all were self-limited and there were no deaths from liver failure, serious hepatic adverse events or instances of clinically apparent liver injury with jaundice).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of infigratinib which is not discussed).
Guagnano V, Furet P, Spanka C, Bordas V, Le Douget M, Stamm C, Brueggen J, et al. (2011). Discovery of3-(2,6-dichloro-3,5-dimethoxy-phenyl)-1-{6-[4-(4-ethyl-piperazin-1-yl)-phenylamino]-pyrimidin-4-yl}-1-methyl-urea (NVP-BGJ398), a potent and selective inhibitor of the fibroblast growth factor receptor family of receptor tyrosine kinase. J Med Chem. (Description of the discovery of a series of FGF receptor inhibitors and selection of infigratinib for its in vitro and in vivo effects in inhibition of FGF receptor 1, 2 and 3 activity and inhibition of growth and proliferation of cancer cell lines that overexpressed FGF receptors).
Arai Y, Totoki Y, Hosoda F, Shirota T, Hama N, Nakamura H, Ojima H, et al. (2014). Fibroblast growth factor receptor tyrosine kinase fusions define a unique molecular subtype of cholangiocarcinoma. Hepatology. (Whole transcriptome sequencing from 8 cholangiocarcinomas identified two FGF receptor fusion genes and screening of different human cancer tissues found FGF receptor fusions in 9 of 102 cholangiocarcinomas [all intrahepatic] but only 1 of 149 colorectal, 1 of 96 hepatocellular, and none of 212 gastric cancers; expression of the fusion kinases in cell cultures led to anchorage independent growth and tumorigenesis when implanted in mice).
Nogova L, Sequist LV, Perez Garcia JM, Andre F, Delord JP, Hidalgo M, Schellens JH, et al. (2017). Evaluation of BGJ398, a fibroblast growth factor receptor 1-3 kinase inhibitor, in patients with advanced solid tumors harboring genetic alterations in fibroblast growth factor receptors: results of a global phase I, dose-escalation and dose-expansion study. J Clin Oncol. (In phase 1 dose escalating studies of infigratinib in 132 patients with advanced, refractory cancers harboring FGF receptor mutations or fusions, the maximum tolerated dose was 125 mg daily and dose defining toxicities included aminotransferase elevations; a regimen of 21 days on and 7 days off was better tolerated that continuous therapy).
Javle M, Lowery M, Shroff RT, Weiss KH, Springfeld C, Borad MJ, Ramanathan RK, et al. (2018). Phase II study of BGJ398 in patients with FGFR-altered advanced cholangiocarcinoma. J Clin Oncol. (Among 61 patients with advanced or metastatic cholangiocarcinoma harboring FGF receptor alterations treated with infigratinib [125 mg daily for 21 days in 28 day cycles], the objective response rate was 15%, occurring only in patients with FGF receptor fusions, while adverse events included hyperphosphatemia in 81%, fatigue 36%, stomatitis 30%, alopecia 26%, hand-foot syndrome 21%, ALT elevations 10%, and hepatic failure in 1 patient [3%]).
Hartley IR, Miller CB, Papadakis GZ, Bergwitz C, Del Rivero J, Blau JE, Florenzano P, et al. (2020). Targeted FGFR blockade for the treatment of tumor-induced osteomalacia. N Engl J Med. (66 year old man with mesenchymal tumor that produced FGF 23 resulting in hypophosphatemia and severe osteomalacia, was treated with infigratinib with a dramatic clinical and biochemical response followed by a relapse when infigratinib was stopped).
Krook MA, Reeser JW, Ernst G, Barker H, Wilberding M, Li G, Chen HZ, et al. (2021). Fibroblast growth factor receptors in cancer: genetic alterations, diagnostics, therapeutic targets and mechanisms of resistance. Br J Cancer. (Review of the association of FGF receptors and cancer chemotherapeutic agents, activating mutations being found in 5% to 10% of cancers overall, but in 10% to 20% of cholangiocarcinomas).
Kang C. (2021). Infigratinib: first approval. Drugs. (Review of the chemical structure, mechanism of action, pharmacokinetics, clinical efficacy and safety of infigratinib shortly after its approval in the US, mentions ALT and AST elevations in list of adverse events but not clinically apparent hepatotoxicity or jaundice).
Javle M, Roychowdhury S, Kelley RK, Sadeghi S, Macarulla T, Weiss KH, Waldschmidt DT, et al. (2021). Infigratinib (BGJ398) in previously treated patients with advanced or metastatic cholangiocarcinoma with FGFR2 fusions or rearrangements: mature results from a multicentre, open-label, single-arm, phase 2 study. Lancet Gastroenterol Hepatol. (Among 108 patients with advanced or metastatic cholangiocarcinoma with FGF2 fusions or rearrangements treated with infigratinib [125 mg for 21 of 28 day cycles], the objective response rate was 23% and adverse events included hyperphosphatemia [77%], stomatitis [55%], fatigue [40%], alopecia [38%], dry eyes [34%], and ALT elevations [15% with 2% above 5 times ULN], but there were no instances of clinically apparent liver injury with jaundice).
Neuzillet C. (2021). Infigratinib in pretreated cholangiocarcinoma with FGFR2 fusions or rearrangements. Lancet Gastroenterol Hepatol. (Editorial in response to Javle et al [2021] comparing results of second-line infigratinib therapy of advanced or metastatic cholangiocarcinoma [objective response rate of 23.1%] with the previous standard chemotherapy [FOLFOX: 7.7%] and the similar FGF receptor kinase inhibitor pemigatinib [35.5%]).

## OTHER REFERENCE LINKS

1 Recent References on Infigratinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Infigratinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Infigratinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Infigratinib)